# Maribavir

## OVERVIEW

### Introduction

Maribavir is an orally available, antiviral agent which inhibits the pUL97 kinase of cytomegalovirus (CMV) and is used to treat refractory forms of post-transplant CMV infection. Maribavir has been associated with low rates of mild-to-moderate serum aminotransferase elevations during therapy but has not been linked to cases of clinically apparent acute liver injury.

### Background

Maribavir (ma rye’ ba vir) is a small molecule inhibitor of the cytomegalovirus (CMV) pUL97 kinase which is needed for the processing of proteins necessary for CMV replication. Maribavir has potent activity against CMV in vitro and in vivo and has been shown to decrease CMV DNA levels in patients with otherwise refractory CMV infection after hematopoietic stem cell transplantation. In contrast, maribavir had little or no efficacy in prevention of CMV infection when given as prophylaxis after transplantation. Maribavir was approved as therapy of adults and children (12 years of age or older and weighing at least 35 kilograms) with refractory CMV infection after hematopoietic cell transplantation in the United States in 2019. Maribavir is available as tablets of 200 mg under the brand name Livtencity. The recommended dose is 400 mg (2 tablets) by mouth twice daily. Maribavir has several drug-drug interactions and is not recommended to be used in combination with ganciclovir or valganciclovir. Side effects include dysgeusia, nausea, vomiting, diarrhea, abdominal pain, and fatigue.

### Hepatotoxicity

In large preregistration clinical trials, ALT elevations occurred in 3.5% of maribavir vs less than 1% of standard therapy in recipients with refractory CMV infection after hematopoietic cell transplantation. The ALT elevations were transient, mild and asymptomatic. In prelicensure studies, there were no instances of clinically apparent liver injury with jaundice. Since the approval of maribavir and its general availability, there have been no reported cases of clinically apparent liver injury with jaundice associated with its use; however, the total clinical experience with maribavir therapy is limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The possible mechanism of hepatotoxicity from maribavir is unknown but may relate to its hepatic metabolism or the drug-drug interactions.

### Outcome and Management

The aminotransferase elevations associated with maribavir therapy were not well characterized in the prelicensure studies as far as timing, duration and severity, but appeared to be self-limited and did not require dose modification or drug discontinuation. In patients who develop ALT or AST elevations above 5 times ULN during therapy, maribavir should be at least temporarily discontinued and restarted only once levels fall to normal or near normal levels. Patients who develop ALT or AST elevations with symptoms or jaundice should discontinue maribavir and restart therapy only if another cause is identified. There is no reason to suggest any cross sensitivity to liver injury between maribavir and the conventional antiviral agents with activity against CMV.

Drug Class: Antiviral Agents

Other Antiviral Agents for Herpes Virus Infections: Acyclovir, Cidofovir, Famciclovir, Foscarnet, Ganciclovir, Letermovir, Valacyclovir, Valganciclovir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Maribavir – Livtencity®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Maribavir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Maribavir | 176161-24-3 | C15-H19-Cl2-N3-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 14 November 2022

Abbreviations: CMV, cytomegalovirus; HSCT, hematopoietic stem cell transplantation.

Núñez M. Herpesviridae treatment. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 512-3. (Review of hepatotoxicity of antiviral agents published in 2013, before the availability of maribavir).
Acosta EP. Antiviral agents (nonretroviral). In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1105-35. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/215596Orig1s000IntegratedR.pdf (FDA Drug Approval website that has product labels [package inserts], letters of approval and full FDA scientific reviews of the new drug applications for safety and efficacy; mentions that one of 234 patients with post-transplant CMV infection treated with maribavir developed hepatic failure, but specific details were not provided and overall rate of ALT elevations above 5 times ULN was 3% versus 0% in patients treated with comparator agents).
Marty FM, Ljungman P, Papanicolaou GA, Winston DJ, Chemaly RF, Strasfeld L, Young JA, et al., Maribavir 1263-300 Clinical Study Group. (2011). Maribavir prophylaxis for prevention of cytomegalovirus disease in recipients of allogeneic stem-cell transplants: a phase 3, double-blind, placebo-controlled, randomised trial. Lancet Infect Dis. (Among 681 adults undergoing allogenic hematopoietic stem cell transplantation [HSCT] given prophylaxis for CMV infection with either maribavir or placebo for up to 12 weeks, CMV disease developed in similar proportions of patients [4% vs 5%] and adverse event rates were similar except for dysgeusia [15% vs 6%]; no mention of ALT elevations or hepatotoxicity).
Papanicolaou GA, Silveira FP, Langston AA, Pereira MR, Avery RK, Uknis M, Wijatyk A, et al. (2019). Maribavir for refractory or resistant cytomegalovirus infections in hematopoietic-cell or solid-organ transplant recipients: a randomized, dose-ranging, double-blind, phase 2 study. Clin Infect Dis. (Among 120 patients with refractory or resistant CMV infection after hematopoietic or solid organ transplantation treated with maribavir [400, 800 or 1200 mg] twice daily for up to 24 weeks, the overall response rate at 6 weeks was 67% and was similar in all dose groups while adverse events led to dose discontinuation in 34% of patients, but there was no mention of liver related adverse events or ALT elevations).
Maertens J, Cordonnier C, Jaksch P, Poiré X, Uknis M, Wu J, Wijatyk A, et al. (2019). Maribavir for preemptive treatment of cytomegalovirus reactivation. N Engl J Med. (Among 156 patients with CMV reactivation after hematopoietic or solid organ transplantation treated with maribavir [400, 800 or 1200 mg] or valganciclovir [900 mg] twice daily for up to 12 weeks, response rates were similar with both drugs [62% vs 56%] but serious adverse events were more common with maribavir [44% vs 32%] as was dysgeusia [40% vs 2%], while neutropenia was less [4% vs 15%]; no mention of ALT elevations or hepatotoxicity).
Kang C. (2022). Maribavir: first approval. Drugs. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of maribavir shortly after its approval in the US; mentions common adverse events of dysgeusia, nausea, diarrhea, vomiting, fatigue and abdominal pain, but does not mention ALT elevations or hepatotoxicity).
Avery RK, Alain S, Alexander BD, Blumberg EA, Chemaly RF, Cordonnier C, Duarte RF, et al., SOLSTICE Trial Investigators. (2022). Maribavir for refractory cytomegalovirus infections with or without resistance post-transplant: Results from a phase 3 randomized clinical trial. Clin Infect Dis. (Among 320 patients with refractory CMV infection after HCST treated with maribavir [400, 800 or 1200 mg twice daily] or valganciclovir for up to 12 weeks, response rates were higher with maribavir [79% vs 67%] and adverse events were mostly mild-to-moderate gastrointestinal symptoms; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Maribavir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Maribavir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Maribavir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Maribavir)